# Trilaciclib

## OVERVIEW

### Introduction

Trilaciclib is an intravenously administered, small molecule inhibitor of cyclin-dependent kinases 4 and 6, that is used to decrease chemotherapy-induced myelosuppression. Serum aminotransferase elevations arise in a small proportion of patients treated with the highest doses of trilaciclib, but episodes of clinically apparent liver injury have not been reported with its use.

### Background

Trilaciclib (trye” la sye’ klib) is a first-in-class, short acting inhibitor of cyclin-dependent kinases 4 and 6, that is used to prevent bone marrow suppression by anticancer therapies. Trilaciclib causes transient G1 cell cycle arrest in hematopoietic cells protecting them against the myelosuppression caused by cytotoxic antineoplastic medications. In animal models and in pilot clinical trials, administration of trilaciclib shortly before starting infusions of cytotoxic antineoplastic agents, lessened the typical decrease in red and white cell counts that occurred with cancer chemotherapy. In several prospective, placebo-controlled randomized trials, infusions of trilaciclib within 4 hours of starting chemotherapeutic agents such as cisplatin, etoposide, and topotecan were associated with fewer episodes of severe neutropenia and neutropenic sepsis but with no change in antineoplastic activity. Trilaciclib was granted accelerated approval for use in chemotherapy in 2021 in the United States for adults with advanced or metastatic small cell lung cancer receiving a platinum-based regimen or a topotecan-based regimen. Trilaciclib is available as a powder for reconstitution in single use vials of 300 mg under the brand name Cosela. The recommended regimen is 240 mg/m^2^ infused over 30 minutes within 4 hours of starting chemotherapy for each day of antineoplastic administration (typically days 1 to 3 of 28-day cycles). Trilaciclib is under evaluation in other chemotherapeutic regimens for other advanced cancers. Side effects can include infusion and hypersensitivity reactions as well as fatigue, headache, nausea and vomiting, poor appetite, weight loss, infusion reactions, and thrombophlebitis. Therapy can also cause decreases in serum calcium, phosphate, and potassium, and elevations in creatinine and aminotransferase levels. Uncommon but potentially severe adverse events include severe hypersensitivity reactions and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure clinical trials of trilaciclib in patients with advanced cancer receiving cytotoxic chemotherapy, serum AST elevations arose in 17% of trilaciclib vs 14% of placebo recipients. The AST elevations were usually self-limited and mild and elevations above 5 times the upper limit of normal (ULN) were uncommon, being found in <1% of treated patients. In the randomized controlled trials supporting the approval of trilaciclib, there were no instances of clinically apparent liver injury, hepatic failure or deaths from liver injury. Since its approval and more general use, there have been no published reports of hepatoxicity attributed to trilaciclib.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum aminotransferase elevations from trilaciclib is unknown, but the pattern of abnormalities suggests a minor degree of direct toxicity. Trilaciclib is metabolized in the liver via the cytochrome P450 system, largely by CYP 3A4 and to a lesser extent by CYP 2C8. Trilaciclib is susceptible to drug-drug interactions with agents that inhibit or induce CYP 3A4 activity, which should be avoided while it is being used.

### Outcome and Management

The product label for trilaciclib does not recommend regular monitoring of liver tests, but if serum aminotransferase levels above 5 times the ULN are identified, therapy should be held until levels fall into the normal or near normal range, at which point it can be started at the same or a reduced dose as clinically indicated and with close continued monitoring. Cross sensitivity to liver injury is uncommon among the antineoplastic small molecule enzyme and receptor inhibitors, but there is no information on shared adverse event sensitivity of trilaciclib with other antineoplastic protein kinase inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Trilaciclib – Cosela®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Trilaciclib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Trilaciclib | 1374743-00-6 | C24-H30-N8-O

## ANNOTATED BIBLIOGRAPHY

References updated: 17 October 2023

Abbreviations: ER, estrogen receptor; HER2, human epidermal growth factor receptor 2; PR, progesterone receptor.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of protein kinase inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss trilaciclib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/214200Orig1s000SumR.pdf (FDA website with initial product label and multidiscipline review of the safety and efficacy of trilaciclib describes 240 patients treated with trilaciclib [122] vs placebo [118] in whom deaths occurred in 75% of each group, serious adverse events in 30% vs 25%, febrile neutropenia 3% vs 6%, any infection 7% vs 10%, fatigue 34% vs 27%, hypocalcemia 24% vs 21%, hypokalemia 22% vs 18%, AST elevations 17% vs 14%, headache 13% vs 9%, infusion site reactions 13% vs 3%, rash 9% vs 6%, and thrombophlebitis 4% vs <1%; no mention of clinically apparent liver injury or deaths from liver failure).
Tan AR, Wright GS, Thummala AR, Danso MA, Popovic L, Pluard TJ, Han HS, et al. Trilaciclib plus chemotherapy versus chemotherapy alone in patients with metastatic trip le-negative breast cancer: a multicentre, randomised, open-label, phase 2 trial. Lancet Oncol. 2019;20:1587-1601. (Among 102 adults with recurrent or metastatic triple negative breast cancer treated with gemcitabine and carboplatin with or without one of two regimens of trilaciclib, indices of myelosuppression and rates of febrile neutropenia were similar in all groups; no mention of ALT elevations or hepatotoxicity). 31575503
Hart LL, Ferrarotto R, Andric ZG, Beck JT, Subramanian J, Radosavljevic DZ, Zaric B, et al. Myelopreservation with trilaciclib in patients receiving topotecan for small cell lung cancer: results from a randomized, double-blind, placebo-controlled phase II study. Adv Ther. 2021;38:350-365. (Among 61 adults with extensive small cell lung cancer treated with topotecan [days 1 to 5 of 21-day cycles] with or without pretreatment with trilaciclib, serious neutropenia was less frequent [41% vs 76%] and shorter in duration [median 1 vs 7 days] as were rates of thrombocytopenia [63% vs 68%] and anemia [53% vs 61%] while side effect rates were usually similar [except headache at 41% vs 36%]; no mention of infusion reactions, ALT elevations or hepatotoxicity). 33123968
Daniel D, Kuchava V, Bondarenko I, Ivashchuk O, Reddy S, Jaal J, Kudaba I, et al. Trilaciclib prior to chemotherapy and atezolizumab in patients with newly diagnosed extensive-stage small cell lung cancer: A multicentre, randomised, double-blind, placebo-controlled Phase II trial. Int J Cancer. 2020;148:2557–70. (Among 105 adults with advanced or metastatic small cell lung cancer treated with trilaciclib vs placebo at the time of intravenous platin/etoposide-based chemotherapy, the rate of severe neutropenia was 1.9% vs 49% and duration of neutropenia 0 vs 4 days, while adverse events were mostly mild and transient, AST elevations arising in 12% vs 4% and being above 5 times ULN in 2% vs none, but there were no liver related discontinuations or fatalities).
Dhillon S. Trilaciclib: first approval. Drugs. 2021;81(7):867-874. (Review of the structure, mechanism of action, history of development, pharmacokinetics, clinical efficacy, and safety of trilaciclib shortly after its approval in the US, the first agent approved for prophylaxis against chemotherapy induced myelosuppression). 33861388
Roskoski R Jr. Properties of FDA-approved small molecule protein kinase inhibitors: a 2022 update. Pharmacol Res. 2022;175:106037. (Comprehensive review of human protein kinases and the 68 small molecular inhibitors that have been approved for use in neoplastic [n=58], autoimmune, cardiovascular, neurologic, and inflammatory diseases; the 68 drugs can be categorized as serine/threonine [n=12], tyrosine [n=42], or dual [n=4] kinase inhibitors, and as tyrosine receptor [n=39] or nonreceptor [n=13] inhibitors; trilaciclib is a non-receptor tyrosine kinase inhibitor and unlike most kinase protein inhibitors is given intravenously to achieve high levels of inhibition of hematopoietic cells to protect them against the cytotoxicity of anticancer drugs, a controversial issue being whether it also protects cancer cell from the cytotoxicity). 34921994
Trilaciclib (Cosela) for prevention of chemotherapy-related myelosuppression. Med Lett Drugs Ther. 2021;63:174-175. (Concise review of the mechanism of action, clinical efficacy, safety, and cost of trilaciclib shortly after its approval in the US mentions that AST elevations occur in more than 10% of treated patients). 35085207
Goel S, Tan AR, Rugo HS, Aftimos P, Andrić Z, Beelen A, Zhang J, et al. Trilaciclib prior to gemcitabine plus carboplatin for metastatic triple-negative breast cancer: phase III PRESERVE 2. Future Oncol. 2022;18:3701-3711. (Rationale for and design of a phase 3 placebo-controlled trial of trilaciclib in adults with metastatic breast cancer negative for estrogen, progesterone and human epidermal growth factor 2 receptors). 36135712

## OTHER REFERENCE LINKS

Recent References on Trilaciclib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Trilaciclib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Trilaciclib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Trilaciclib)